# Fidaxomicin

## OVERVIEW

### Introduction

Fidaxomicin is a semisynthetic macrolide antibiotic used to treat Clostridium difficile-associated diarrhea in adults. Fidaxomicin has minimal systemic absorption and has not been linked to serum enzyme elevations during therapy or to instances of clinically apparent, acute liver injury.

### Background

Fidaxomicin (fye dax" oh mye' sin) is a semisynthetic macrolide antibiotic that is minimally absorbed and has potent bactericidal activity against Clostridia, but minimal or no antibacterial activity against normal gastrointestinal flora. Because of its lack of oral absorption and restricted antibacterial activity, fidaxomicin was developed as an oral therapy for Clostridium difficile and was approved for this use in the United States in 2011. Fidaxomicin is available in tablets of 200 mg under the brand name Dificid. The typical regimen is 200 mg twice daily for 10 days which is effective in eradicating C. difficile in 80% to 90% of patients. Fidaxomicin is generally well tolerated, but side effects can include nausea, vomiting, abdominal pain, diarrhea, dyspepsia, headache, gastrointestinal hemorrhage, anemia and neutropenia. Rare, but potentially severe adverse events include hypersensitivity reactions (rash, angioedema) and drug resistant bacterial infection.

### Hepatotoxicity

In large clinical trials, therapy with fidaxomicin for ten days was associated with a low rate of serum aminotransferase elevations [1% to 3.2%], but rates with comparator agents such as vancomycin were similar [up to 2.7%]. There have been no reports of clinically apparent liver injury attributed to fidaxomicin. However, other oral macrolide antibiotics have been linked to many episodes of acute liver injury which can be severe and have resulted in fatalities. The onset of macrolide associated liver injury is typically 1 to 3 weeks after starting the drug and can arise after it is stopped. The injury is typically cholestatic, but can be mixed or hepatocellular. The hepatocellular cases are more likely to be severe and can result in acute liver failure. However, in most instances, recovery occurs within 4 to 8 weeks of withdrawal of the macrolide. No such cases, however, have been linked to use of fidaxomicin, which unlike the other macrolides is not absorbed orally.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

Fidaxomicin is minimally absorbed systematically and the cause of serum enzyme elevations or liver injury from its use is unknown.

### Outcome and Management

The minor serum aminotransferase elevations that appear during therapy with fidaxomicin are usually benign, asymptomatic and resolve rapidly once fidaxomicin is stopped. It is unclear whether there is cross sensitivity to hepatic injury about the different macrolide antibiotics, but after severe injury from one macrolide, it is prudent to avoid use of the others.

Drug Class: Antiinfective Agents, Macrolide Antibiotics

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Fidaxomicin – Dificid®

DRUG CLASS

Antiinfective Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Fidaxomicin)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Fidaxomicin | 873857-62-6 | C52-H74-Cl2-O18 | Fidaxomicin chemical structure

## ANNOTATED BIBLIOGRAPHY

References updated: 08 August 2017

Moseley RH. Macrolide antibiotics. Hepatotoxicity of antimicrobials and antifungal agents. In, Kaplowitz N, DeLeve LD, eds. Drug-induced Liver Disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 466-7. (Expert review of macrolide antibiotic induced liver injury does not discuss fidaxomicin).
MacDougall C, Chambers HF. Macrolides and ketolides. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 1529-34. (Textbook of pharmacology and therapeutics).
Leitner JM, Graninger W, Thalhammer F. Hepatotoxicity of antibacterials: pathomechanisms and clinical data. Infection 2010; 38: 3-11. (Review of antibiotic associated liver injury; the macrolide antibiotics may cause cholestatic hepatitis at an estimated rate of 3.6 per 100,000 prescriptions for erythromycin, 3.8 for clarithromycin, and 5.5 for telithromycin, compared to 10 for sulfonamides and 2000 per 100,000 for isoniazid; no mention of fidaxomicin). 20107858
Reuben A, Koch DG, Lee WM; Acute Liver Failure Study Group. Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology 2010; 52: 2065-76. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, only one of which was due to a macrolide antibiotic [clarithromycin] and none were attributed to fidaxomicin). 20949552
Louie TJ, Miller MA, Mullane KM, Weiss K, Lentnek A, Golan Y, Gorbach S, et al.; OPT-80-003 Clinical Study Group. Fidaxomicin versus vancomycin for Clostridium difficile infection. N Engl J Med 2011; 364: 422-31. (Among 629 adults with acute, symptomatic C. difficile infection treated with oral vancomycin or fidaxomicin [200 mg twice daily] for 10 days, both response and adverse event rates were similar with both agents; 3 of 300 [1%] fidaxomicin- compared to none of 323 vancomycin-treated subjects had ALT or AST elevations that were considered “serious”, but all resolved upon completing therapy). 21288078
Fidaxomicin (Dificid) for Clostridium Difficile Infection. Med Lett Ther 2011; 53: 23-4. (Concise review of the pharmacology, efficacy, safety and cost of fidaxomicin in comparison to vancomycin and metronidazole as therapy of C. difficile infection, mentions possible side effects of nausea, vomiting, abdominal pain, hemorrhage, anemia and neutropenia, but does not mention ALT elevations or hepatotoxicity). 21921871
Weiss K, Allgren RL, Sellers S. Safety analysis of fidaxomicin in comparison with oral vancomycin for Clostridium difficile infections. Clin Infect Dis 2012; 55 Suppl 2: S110-5. (Review of the safety of fidaxomicin from preclinical and clinical studies including results from 612 patients with C. difficile infection mentions that fidaxomicin was “well tolerated with a safety profile comparable to oral vancomycin”, with liver test abnormalities arising in 3.2% fidaxomicin- vs 2.6% vancomycin-treated patients, and none in either group developing clinically apparent liver injury with jaundice). 22752858
Chen LF, Anderson DJ. Efficacy and safety of fidaxomicin compared with oral vancomycin for the treatment of adults with Clostridium difficile-associated diarrhea: data from the OPT-80-003 and OPT-80-004 studies. Future Microbiol 2012; 7: 677-83. (Summary of results from two phase 2 trials comparing fidaxomicin to vancomycin for symptomatic C. difficile associated diarrhea mentions that there were no significant drug-drug interactions and no “alterations of laboratory results attributable to fidaxomicin”). 22702523
Cornely OA, Crook DW, Esposito R, Poirier A, Somero MS, Weiss K, Sears P, et al.; OPT-80-004 Clinical Study Group. Fidaxomicin versus vancomycin for infection with Clostridium difficile in Europe, Canada, and the USA: a double-blind, non-inferiority, randomised controlled trial. Lancet Infect Dis 2012; 12: 281-9. (Among 535 patients with acute C. difficile infection treated orally with either fidaxomicin or vancomycin for 10 days, cure rates were similar between the two groups [92% vs 91%] and overall and serious adverse event rates were not different; no mention of ALT elevations or hepatotoxicity). 22321770
Fehér C, Múñez Rubio E, Merino Amador P, Delgado-Iribarren Garcia-Campero A, Salavert M, Merino E, Maseda Garrido E, et al. The efficacy of fidaxomicin in the treatment of Clostridium difficile infection in a real-world clinical setting: a Spanish multi-centre retrospective cohort. Eur J Clin Microbiol Infect Dis 2017; 36: 295-303. (Among 72 Spanish patients with C. difficile infection treated with fidaxomicin, the cure rate was 90% and adverse events were uncommon, although 2 patients had ALT elevations (mild-to-moderate), but neither was attributed to the drug treatment). 27718071

## OTHER REFERENCE LINKS

1. Recent References on Fidaxomicin: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Fidaxomicin+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Fidaxomicin: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Fidaxomicin)